# Brensocatib

## OVERVIEW

### Introduction

Brensocatib is an oral small molecule inhibitor of dipeptidyl peptidase 1 (DPP-1) used in the treatment of bronchiectasis. Brensocatib has been associated with a low rate of serum aminotransferase elevations during therapy but has not been linked with instances of clinically apparent liver injury.

### Background

Brensocatib (bren” soe kat’ ib) is an oral, small molecule inhibitor of dipeptidyl peptidase 1 (DPP-1, also known as cathepsin C), a lysosomal cysteine protease responsible for the activation of neutrophil serine proteases during neutrophil maturation in the bone marrow. By inhibiting DPP-1, brensocatib reduces the activity of these proteases, which are implicated in the neutrophilic inflammation and airway damage that characterize bronchiectasis. In two randomized controlled trials in patients with bronchiectasis not due to cystic fibrosis, brensocatib reduced the annualized rate of pulmonary exacerbations and, at the higher dose, slowed the decline in lung function compared with placebo. Brensocatib was approved for use as therapy of non-cystic fibrosis-related bronchiectasis in the United States in 2025. It is available in tablets of 10 and 25 mg under the brand name Brinsupri. The recommended dose for both adults and children (12 years of age or older) is 10 or 25 mg orally once daily. Common side effects include upper respiratory tract infections, headache, cough, rash, dry skin, hyperkeratosis, gingivitis, and hypertension. Rare but potentially serious adverse events include serious skin reactions, severe infections, and immunodeficiency.

### Hepatotoxicity

In the large pre-registration randomized controlled trials of brensocatib in non-cystic fibrosis bronchiectasis, adverse event rates were similar with both doses and placebo. Elevations in ALT levels above 3 times the upper limit of normal (ULN) arose in only 1% of 1154 patients on brensocatib vs none of 581 patients on placebo. Elevations above 5 times ULN arose in 0.1% of treated patients and there were no ALT elevations accompanied by jaundice. Since its approval, there have been no published reports of clinically apparent liver injury attributed to brensocatib, but clinical experience with the drug has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which brensocatib might cause liver injury is not known. It is metabolized in the liver primarily by CYP 3A4, and a toxic or immunogenic intermediate of its metabolism might be a cause of liver injury. Brensocatib is susceptible to drug-drug interactions with inhibitors or inducers of CYP 3A4, but the clinical significance of these changes has not been shown. Dose modifications are not necessary in patients with even severe hepatic impairment.

### Outcome and Management

While brensocatib has been linked to low rates of serum aminotransferase elevations during therapy, it has not been associated with instances of clinically apparent liver injury. There is no specific information on cross reactivity of liver injury with other DPP-1 inhibitors.

Drug Class: Antiinflammatory Agents; Respiratory Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Brensocatib – Brinsupri®

DRUG CLASS

Respiratory Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Brensocatib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Brensocatib | 1802148-05-5 | C23H24FN4O4 | SID: 394250515

## ANNOTATED BIBLIOGRAPHY

References updated: 07 September 2026

Abbreviations used: ULN, upper limit of normal; FEV1, forced expiratory volume in one second.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of antibiotics published in 1999, before the availability of brensocatib).
Drugs@FDA: FDA–Approvals. 2024.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/217673Orig1s000OtherR.pdf (FDA website with product labels and Integrated Review of the data on efficacy and safety of brensocatib submitted in support of its approval as therapy of bronchiectasis mentions that in the large pre-registration controlled trial of brensocatib, ALT elevations above 3 times ULN arose in 1% of brensocatib recipients vs none of placebo controls and elevations above 5 times ULN occurred in 0.1% vs none; and while 2 patients discontinued therapy because of liver test elevations, there were no ALT elevations with jaundice or cases of clinically apparent liver injury).
Chalmers JD, Haworth CS, Metersky ML, Loebinger MR, Blasi F, Sibila O, O’Donnell AE, et al; WILLOW Investigators. Phase 2 trial of the DPP-1 inhibitor brensocatib in bronchiectasis. N Engl J Med. 2020;383:2127-2137. (Among 256 patients with bronchiectasis treated with brensocatib [10 or 25 mg] or placebo once daily for 24 weeks, time to first exacerbation was prolonged with both doses of brensocatib compared with placebo, and adverse events reflecting reduced neutrophil serine protease activity [such as skin and dental effects] were more frequent with brensocatib; no mention of significant ALT elevations or hepatotoxicity). 32897034
Chalmers JD, Burgel PR, Daley CL, De Soyza A, Haworth CS, Mauger D, Loebinger MR, et al; ASPEN Investigators. Phase 3 trial of the DPP-1 inhibitor brensocatib in bronchiectasis. N Engl J Med. 2025;392(16):1569-1581. (Among 1721 patients with bronchiectasis treated with brensocatib [10 or 25 mg] vs placebo daily for 52 weeks, the annualized rate of pulmonary exacerbations was lower with both brensocatib doses [1.02 and 1.04] vs placebo [1.29], and the decline in FEV1 was less with the higher dose; adverse event rates were similar in the three groups, with a higher rate of hyperkeratosis in the brensocatib groups; no mention of ALT elevations or hepatotoxicity). 40267423

## OTHER REFERENCE LINKS

1. Recent References on Brensocatib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Brensocatib%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Brensocatib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Brensocatib)